# Revefenacin

## OVERVIEW

### Introduction

Revefenacin is a synthetic anticholinergic agent that is used as a once daily, nebulized inhalant for maintenance treatment of patients with chronic obstructive pulmonary disease. Revefenacin has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Revefenacin (rev" e fen' a sin) is a synthetic anticholinergic which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, which decreases bronchial smooth muscle contractions and can alleviate bronchospasm in patients with chronic obstructive pulmonary disease (COPD). Revefenacin has potent activity against muscarinic acetylcholine receptors found in bronchial smooth muscle (M3). Its quaternary ammonium structure decreases its ability to cross lipid membranes such as the blood brain barrier. Revefenacin was approved for use in the United States in 2018 for use as a once daily respiratory inhalant for maintenance treatment of bronchospasm associated with COPD. Revefenacin is available under the brand name Yupelri as an inhalation solution in multiuse vials of 175 mcg in 3 mL. The recommended dose in adults is 175 mcg by inhalation once daily. When given by inhaler, revefenacin has minimal systemic absorption and few anticholinergic side effects. Side effects are mild but can include the headache, cough, symptoms of upper respiratory infections and back pain. Revefenacin is not recommended for patients with hepatic impairment, and concurrent use of other anticholinergic agents should be avoided. Potential severe adverse events include paradoxical bronchospasm, narrow-angle glaucoma, urinary retention and immediate hypersensitivity reactions.

### Hepatotoxicity

Like other anticholinergic agents, revefenacin has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. Another reason for its hepatic safety may relate to its low systemic absorption when administered by inhaler.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Revefenacin – Yupelri®

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Revefenacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Revefenacin | 864750-70-9 | C35-H43-N5-O4 | Revefenacin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Abbreviations: COPD, chronic obstructive pulmonary disease.

Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 727-49. (Textbook of pharmacology and therapeutics).
Pudi KK, Barnes CN, Moran EJ, Haumann B, Kerwin E. A 28-day, randomized,double-blind, placebo-controlled, parallel group study of nebulized revefenacin in patients with chronic obstructive pulmonary disease. Respir Res 2017; 18: 182. (Among 355 patients with chronic obstructive pulmonary disease [COPD] treated with nebulized revefenacin [44, 88, 175, or 350 mcg] or placebo once daily for 28 days, forced expiratory volume improved more with the higher doses than with placebo, and adverse event rates were similar in all groups, systemic anticholinergic effects being uncommon). 29096627
Quinn D, Barnes CN, Yates W, Bourdet DL, Moran EJ, Potgieter P, Nicholls A, et al. Pharmacodynamics, pharmacokinetics and safety of revefenacin (TD-4208), a long-acting muscarinic antagonist, in patients with chronic obstructive pulmonary disease (COPD): Results of two randomized, double-blind, phase 2 studies. Pulm Pharmacol Ther 2018; 48: 71-9. (Among 59 patients with COPD treated with once daily nebulized revefenacin or placebo for 7 days, forced expiratory volume improved with all doses of revefenacin compared to placebo, and adverse events were mild and similar in rates in all groups). 28987804
Heo YA. Revefenacin: first global approval. Drugs 2019; 79: 85-91. (Review of the development, clinical efficacy and safety of revefenacin, an inhaled, long acting muscarinic antagonist approved for use in patients with COPD; mentions that the frequency and severity of adverse events were “generally similar across treatment groups”; no mention of ALT elevations or hepatotoxicity). 30560478
Revefenacin (Yupelri) for COPD. Med Lett Drugs Ther 2019; 61: 14-5. (Concise review of the maintenance therapy of COPD and the clinical efficacy, safety and costs of revefenacin shortly after its approval in the US as a once daily nebulized inhalant for the management treatment of patients with COPD; does not mention ALT elevations or hepatotoxicity). 30856160
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that there were no differences in laboratory test results between revefenacin and comparator arms of pre-licensure clinical trials and the one patient who developed clinically apparent liver injury during revefenacin treatment was found to have pancreatic cancer as a cause of jaundice).

## OTHER REFERENCE LINKS

1. Recent References on Revefenacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Revefenacin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Revefenacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Revefenacin)